# Guarana

## OVERVIEW

### Introduction

Guarana is an extract of roasted and pulverized seeds of the plant Paullinia cupana which is indigenous to the Amazon Basin and whose major active components are caffeine and other xanthine alkaloids such as theophylline and theobromine. Guarana has been used as a stimulant and tonic to treat fatigue, decrease hunger and thirst and for headaches and dysmenorrhea. In conventional doses, guarana has few side effects and has not been linked to episodes of liver injury or jaundice.

### Background

Guarana is derived from the seeds of the plant Paullinia cupana which is native to the Amazon Basin and is cultivated as a source of guarana and caffeine in South America. The P. cupana seeds contain a high concentration of caffeine (2% to 8%), far higher than in coffee beans (1% to 3%). The seeds are also rich in other xanthine alkaloids such as theophylline and theobromine as well as catechins, epicatechins and procyanidins. Guarana is produced by shelling and washing the seeds, followed by drying or roasting. The seeds are then pulverized into a powder that can be used as a food favoring, to prepare tea or as a component in energy drinks or multiingredient dietary supplements. Guarana has caffeine like effects on the heart, vasculature and central nervous system. In traditional medicine, guarana was used as a stimulant, mild diuretic and as a tonic to increase wakefulness, quell hunger and thirst, and to treat headaches, dysmenorrhea and digestive disorders. More recently, guarana has been purported to have beneficial effects on energy and endurance, as a weight loss agent, and for cognitive enhancement to increase concentration and memory. While guarana may have a mild effect on energy levels, cognition and satiety, these are generally short-lived and have minimal lasting clinical effects. In high doses, guarana can cause tremor, jitteriness, agitation, confusion, hypertension and dehydration. Most of its beneficial effects as well as its side effects can be explained by its caffeine content. Guarana is available in tablets and capsules, as liquid and in multiple commercial multiingredient supplements, particularly weight loss products and energy drinks. Daily doses range from 200 to 1000 mg daily. The use of multiple herbal products containing guarana and other sources of caffeine can result in caffeine toxicity.

### Hepatotoxicity

In small studies on guarana, there were no reports liver injury or serum enzyme elevations during treatment. Despite extensive use, guarana has not been convincingly linked to cases of clinically apparent liver injury. In large case series of drug- and HDS-related liver injury, guarana is not listed as implicated even in a single case. Use of high doses of guarana given long term in persons with preexisting liver disease or cirrhosis is discouraged.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which guarana might cause liver injury is unknown. Guarana is found in many multiingredient dietary supplements and energy drinks, and it is sometimes one of many ingredients in products implicated in causing liver injury. The contribution of guarana to these cases is, however, not particularly likely.

Drug Class: Herbal and Dietary Supplements

Other names: Paullinia cupana.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Guarana – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/935.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Guarana | 84929-28-2 (https://pubchem.ncbi.nlm.nih.gov/substance/135349000) | Herbal | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 28 January 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not guarana).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of guarana).
Guarana. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 425-8. (Compilation of short monographs on herbal medications and dietary supplements).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found no attributed to guarana).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not guarana).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; guarana is not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but does not list or mention horsetail).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing guarana).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention guarana).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to guarana).
Martins SPDS, Ferreira CL, Del Giglio A. (2017). Placebo-controlled, double-blind, randomized study of a dry guarana extract in patients with head and neck tumors undergoing chemoradiotherapy: effects on fatigue and quality of life. J Diet Suppl. (Among 60 adults with head and neck carcinoma undergoing radiotherapy and cisplatin chemotherapy treated with either guarana [25 mg] and placebo twice daily for 6 weeks, there was no difference in fatigue scores or quality of life changes between the two groups and no differences in adverse event rates or types).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss guarana).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while no case was attributed to guarana).
Patrick M, Kim HA, Oketch-Rabah H, Marles RJ, Roe AL, Calderón AI. (2019). Safety of guarana seed as a dietary ingredient: a review. J Agric Food Chem. (Review of the phytochemistry and safety of guarana concludes that it is not associated with any health risk when taken in doses 75 to 1200 mg of extract daily, that high doses can be associated with tachycardia, anxiety, agitation and gastrointestinal intolerance, symptoms typical of caffeine overdose; no mention of ALT elevations or hepatotoxicity).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; guarana was not implicated in any cases).
de Araujo DP, Pereira PTVT, Fontes AJC, Marques KDS, de Moraes ÉB, Guerra RNM, Garcia JBS. (2021). The use of guarana (Paullinia cupana) as a dietary supplement for fatigue in cancer patients: a systematic review with a meta-analysis. Support Care Cancer. (Systematic review of the safety and efficacy of guarana in treating fatigue in patients with cancer identified 7 studies of 383 patients, among whom guarana and placebo had similar effects on fatigue, depression, sleep, anxiety and quality of life and both had similar rates of adverse events [tachycardia, insomnia, nausea and anxiety]; no mention of ALT elevations or hepatotoxicity).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while guarana was not implicated in any cases).
Torres EAFS, Pinaffi-Langley ACDC, Figueira MS, Cordeiro KS, Negrão LD, Soares MJ, da Silva CP, et al. (2022). Effects of the consumption of guarana on human health: A narrative review. Compr Rev Food Sci Food Saf. (Extensive review of the chemical composition of guarana, its pharmacology, biologic effects in vitro and in animal models, efficacy in human studies of mental health, depression, dyslipidemia, diabetes, obesity and cancer, and its safety and tolerability; no mention of ALT elevations during therapy or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Guarana: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Guarana+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Guarana: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Guarana)